# Cardiac Glycosides

## OVERVIEW

### Introduction

Digitalis and its derivatives such as digoxin and digitoxin are cardiac glycosides used typically in the therapy of congestive heart failure and atrial fibrillation. The cardiac glycosides have not been linked to serum enzyme elevations during therapy or with instances of clinically apparent liver injury.

### Background

Digitalis (dij" i tal' is), digoxin (di jox' in) and digitoxin (dij" i tox' in) are cardiac glycosides that enhance myocardial contractility, probably by increasing levels of myocardial cytosolic calcium because of inhibition of sodium-potassium ATPase. Originally derived from the purple foxglove flower (Digitalis purpurea), the cardiac glycosides have been used in clinical medicine for more than two centuries. Once used as first-line agents for congestive heart failure and atrial fibrillation, the cardiac glycosides have been replaced by agents that are better tolerated and have been shown to improve long term survival such as the ACE inhibitors and beta-blockers. The cardiac glycosides are now reserved largely for patients with left ventricular systolic dysfunction and atrial fibrillation or for patients with congestive heart failure in sinus rhythm and residual symptoms despite maximal alternative therapy. Digitalis has been available for over a century. Digoxin, derived from Digitalis lanatus, was introduced as having more reliable pharmacokinetics and remains the major form of cardiac glycosides used today. The cardiac glycosides are approved treatment of mild-to-moderate congestive heart failure and for control of the ventricular response rate in patients with atrial fibrillation. Digoxin is available in tablets of ranging from 0.0625 to 0.5 mg generically and under the brand name Lanoxin. The typical dose is 0.125 to 0.25 mg daily, but dosing is often individualized because of tolerance and effect. Digoxin is also available in solution for intravenous administration as well as an oral solution. The cardiac glycosides have many side effects that are largely dose related and require careful monitoring of drug levels. The most common side effects include dizziness, fatigue, headache, anxiety, gastrointestinal upset, change in taste and blurred vision. Severe side effects include seizures and coma, heart block, atrial and ventricular arrhythmias and sudden cardiac death.

### Hepatotoxicity

In clinical trials, digoxin was not associated with serum aminotransferase or alkaline phosphatase elevations. Despite widespread use for many decades, the cardiac glycosides have not been implicated in cases of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The safety of the cardiac glycosides is probably due to the low doses used (less than 1 mg daily) and the serious cardiac and neurologic complications that accompany use of higher doses that might be required for liver injury. The mechanism by which digoxin or digitalis might cause liver injury is unknown. Digoxin is minimally metabolized in the liver and does not materially affect the activity of cytochrome P450 enzymes.

Drug Class: Cardiac Glycosides

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Digoxin – Lanoxin®

DRUG CLASS

Cardiac Glycosides

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=digoxin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Digoxin | 20830-75-5 | C41-H64-O14 | Digoxin structure
Digitoxin | 71-63-6 | C41-H64-O13 | Digitoxin structure

## ANNOTATED BIBLIOGRAPHY

References updated: 03 January 2018

Zimmerman HJ. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 642-4. (Expert review of hepatotoxicity published in 1999 does not discuss the cardiac glycosides).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity of cardiovascular agents does not discuss the cardiac glycosides).
Lucena MI, Stephens C, García-Cortés M, Andrade RJ. Hepatotoxic potential. Causality assessment. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 290. (Review of the potential of different medications to cause liver injury mentions that there is little evidence to implicate digoxin in toxic liver damage despite years of use).
Maron BA, Rocco TP. Cardiac glycosides. Pharmacology of congestive heart failure. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 801-4. (Textbook of pharmacology and therapeutics).
Hochrein H. [Letter: Liver toxicity of digitalis glycosides]. Dtsch Med Wochenschr 1975 Apr 18; 100 (16): 913. German. (Answer to the question of whether digitalis can cause liver injury mentions that there is no evidence that the cardiac glycosides cause liver injury even at high doses, and that the major concern would be the possibility of increased risk of cardiac complications of glycosides in patients with advanced liver disease). 1122858
Bigger JT Jr. Digitalis toxicity. J Clin Pharmacol 1985; 25: 514-21. (Review of the toxicity of cardiac glycosides with conventional as well as excessive doses, focusing upon neurologic [confusion, stupor, coma, seizures] and cardiac side effects [brady- and tachy-arrhythmias] as well as evolving data suggesting a decrease in survival when used after myocardial infarction). 3905880
Digitalis Investigation Group. The effect of digoxin on mortality and morbidity in patients with heart failure. N Engl J Med 1997; 336: 525-33. (Among 6800 patients with congestive heart failure treated with digoxin or placebo with an average follow up of 3 years, survival rates were similar in the two groups, but hospitalizations for worsening heart failure were less; no mention of ALT elevations or hepatotoxicity). 9036306
Turakhia MP, Santangeli P, Winkelmayer WC, Xu X, Ullal AJ, Than CT, Schmitt S, et al. Increased mortality associated with digoxin in contemporary patients with atrial fibrillation: findings from the TREAT-AF study. J Am Coll Cardiol 2014; 64: 660-8. (Retrospective analysis of healthcare data from the VA system identified 122,465 patients with atrial fibrillation, 23% of whom received digoxin; mortality was higher with digoxin use, but rates of death were not reported). 25125296
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to a cardiac glycoside). 25754159
Drugs for chronic heart failure. Med Lett Drugs Ther 2015; 57 (1460): 9-13. (Concise review of drugs approved for use in treatment of congestive heart failure mentions that digoxin can improve symptoms of congestive heart failure but does not prolong survival, the most common adverse events being conduction disturbances, cardiac arrhythmias, nausea, vomiting, confusion and visual disturbances). 25581106

## OTHER REFERENCE LINKS

1. Recent References on Digoxin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(digoxin)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=digoxin) Trials on Digoxin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=digoxin)